# Niacin

## OVERVIEW

### Introduction

Niacin, also known as nicotinic acid and vitamin B3, is a water soluble, essential B vitamin that, when given in high doses, is effective in lowering low density lipoprotein (LDL) cholesterol and raising high density lipoprotein (HDL) cholesterol, which makes this agent of unique value in the therapy of dyslipidemia. Niacin can cause mild-to-moderate serum aminotransferase elevations and high doses and certain formulations of niacin have been linked to clinically apparent, acute liver injury which can be severe as well as fatal.

### Background

Niacin (nye" a sin) is a soluble B vitamin and pyridine derivative and an essential dietary element, deficiency of which causes pellagra. The recommended dietary allowance (RDA) of this vitamin is 14 to 16 mg daily in adults, and slightly more for pregnant women (18 mg) and less for children (2 to 12 mg). Niacin given at or around these doses is not associated with significant side effects or liver injury. Niacin is a component of most multivitamin and vitamin B preparations in concentrations close to the minimum daily requirement, which are not effective in lowering lipid levels. Niacin is also found in many herbal mixtures and energy drinks, but generally in low or modest doses.

The doses of niacin used in the therapy of hyperlipidemia are far higher than the RDA and are generally in the range of 1 to 6 grams daily. When given at these doses, niacin has been shown to increase HDL and lower LDL cholesterol levels and to decrease rates of cardiovascular events in high risk individuals. The mechanism of action of niacin in hyperlipidemia is not well understood, but is believed to be related to inhibition of cAMP signaling pathways in adipocytes, which results in decreased release of lipids from fat cells. Niacin was officially approved for use in the United States in 1957 and is still widely used, although its role in management of hyperlipidemia in patients taking statins and other cholesterol lowering agents remains uncertain and controversial. Regular niacin is available in multiple generic forms, under several brand names (including Niacor), in many concentrations as either tablets or capsules from 50 to 1,000 mg each. When used to treat hyperlipidemia, regular niacin is generally referred to as intermediate release [IR] niacin. IR-niacin must be taken several times daily and is associated with a high rate of cutaneous flushing. The recommended dosage for hyperlipidemia is 1 to 6 grams daily, starting at low doses (100 mg three times daily) and increasing at weekly intervals based upon tolerance and effect. Sustained release [SR] formulations of niacins have been developed which are available over-the-counter. SR niacin can be taken once daily and is less likely to cause flushing, but is not approved for use in hyperlipidemia and has been associated with a high rates of hepatotoxicity in some studies. Extended release (ER) capsules and tablets of niacin are available in concentrations ranging from 125 to 1,000 mg, which are approved for use in hyperlipidemia and have not been associated with a higher rate of hepatotoxicity compared to regular niacin. Niacin ER is available by prescription and over-the-counter in generic forms and under several brand names such as Niaspan and Niobid. In recent years the clinical use of niacin has decreased, but currently more than 1 million prescriptions are filled yearly. The recommended daily dosage of niacin ER ranges from 500 to 2,000 mg generally given once daily at bedtime. Niacin is also available in combination with other lipid lowering drugs such as lovastatin (Advicor). Common side effects of niacin include nausea, fatigue, pruritus and flushing; flushing being a major dose-limiting side effect. Less common but potentially severe adverse reactions with long term use include increase risk of serious bleeding, infections, myopathy and hyperglycemia and worsening as well as de novo development of diabetes.

### Hepatotoxicity

Niacin in doses above 500 mg daily causes transient, asymptomatic elevations in serum aminotransferase levels in up to 20% of people. The elevations are rarely greater than 3 times the upper limit of the normal range and usually resolve spontaneously even with continuation of the drug. The effect is partially dose related and is more common with doses above 3 g/day. In some patients, there is an overall decrease in serum proteins synthesized by the liver and, in some instances, coagulopathy with an increase in prothrombin time and decline in serum albumin, coagulation factors and apolipoproteins. These changes resolve rapidly upon stopping therapy and may not recur with lower doses.

Niacin can also cause serious hepatotoxicity, but this is uncommon. Significant hepatotoxicity is particularly common with high doses of sustained release niacin. In many cases, the injury becomes apparent after a dose increase or after switching from the regular crystalline to a sustained release form. The pattern is primarily hepatocellular, although cases with a cholestatic pattern have been described. The patients present with jaundice, itching, nausea, vomiting and fatigue. When the injury is the result of switching from the crystalline to the sustained release form, the injury may present acutely within days or a few weeks with a prodromal period of nausea, vomiting and abdominal pain, that is followed by jaundice and pruritus. Early during the injury serum aminotransferase levels are very high and then usually fall rapidly with discontinuation or dose lowering. The clinical phenotype resembles acute hepatic necrosis, suggesting a direct toxic effect. Imaging studies of the liver may reveal areas of hypodensity ("starry sky liver") interpreted as focal fatty infiltration that resolves after stopping the drug. Liver biopsy typically shows varying degrees of centrolobular necrosis with only mild inflammation.

Likelihood score: A[HD] (well known cause of clinically apparent liver injury when given in high doses).

### Mechanism of Injury

The mechanism of hepatotoxicity is assumed to be an intrinsic toxic reaction related to high serum levels of niacin that overwhelm the high affinity, low concentration nicotinic acid receptors (that are responsible for the flushing response). The finding that niacin can be restarted at lower doses after an episode of clinically apparent injury indicates that the hepatic damage is unlikely to be idiosyncratic or due to hypersensitivity.

### Outcome and Management

Niacin hepatotoxicity appears to be dose dependent and more common with the sustained release form of the drug. Hepatotoxicity is less common with regular, crystalline niacin or extended release niacin. Most cases are mild and resolve rapidly upon stopping the medication, although in some instances, the injury is acute and severe and progresses to liver failure that is fatal or requires emergency liver transplantation. Complete resolution of the clinical symptoms is expected within days of stopping niacin, whereas serum enzyme elevations may require several weeks or months to resolve. Rechallenge with the same form leads to rapid recurrence and should be avoided. If the injury occurred after switching to a SR formulation, the crystalline form of niacin may be restarted at a lower dose and with caution.

Drug Class: Antilipemic Agents; Vitamins

## CASE REPORT

### Case 1. Hepatocellular hepatitis with jaundice associated with high doses of niacin.(1)

A 41 year old man with a history of taking 4.5 grams of niacin daily for 6 months presented with nausea, anorexia, weakness and abdominal pain followed by jaundice. He was icteric but had no fever or rash. Blood tests showed marked elevations in serum aminotransferase levels and hyperbilirubinemia (Table). Tests for hepatitis B and for autoantibodies were negative. An initial prothrombin time was 28.5 seconds, but it corrected within 3 days of stopping niacin. A liver biopsy showed submassive lobular collapse, marked cholestasis, ballooned hepatocytes and mild fibrosis. Once niacin was stopped, he improved rapidly and serum enzymes fell to normal within a month. Review of this history revealed that he had developed jaundice while taking niacin in the past, had recovered on stopping, but nevertheless began taking it again.

#### Key Points

Medication: | Niacin (4.5 g daily)
Pattern: | Hepatocellular (R=24)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 6 months
Recovery: | 4 days for symptoms, 49 days for ALT
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
0 | | Niacin started, gradually increasing to 4.5 g/day
20 weeks | | Admission: niacin stopped | | | Nausea and jaundice
20 weeks | 0 | 3300 | 379 | 7.2 | Protime 28.5
| 2 days | 2155 | 343 | 8.0
| 4 days | 1212 | 299 | 6.6 | Protime 12.5
21 weeks | 9 days | 237 | 193 | 2.2 | Discharged
6 months | 7 weeks | 35 | 78 | 0.7
8 months | 12 weeks | 26 | 57 | 0.3
Normal Values | | <41 | <115 | <1.2

#### Comment

This is a typical example of hepatotoxicity from high doses of niacin. The delayed latency was probably a result of the gradual increase in dose, the hepatic injury triggered by reaching critical levels. Serum aminotransferase levels were markedly elevated and there was a prompt improvement with stopping therapy. The prolongation of the prothrombin time indicated the severity and acuteness of the injury, and the biopsy confirmed this, showing submassive necrosis and collapse. Multiple such episodes with taking niacin can lead to posthepatitic cirrhosis. Note that if the patient had stopped niacin a week before being tested, serum aminotransferase elevations would be less impressive and the enzyme pattern would be considered mixed or cholestatic.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Niacin – Generic, Niacor®, Niaspan®

DRUG CLASS

Antilipemic Agents; Vitamins

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=niacin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Niacin | 59-67-6 | C6-H5-N-O2

## CITED REFERENCE

1 Patterson DJ, Dew EW, Gyorkey F, Graham DY. (1983). Niacin hepatitis. South Med J.

## ANNOTATED BIBLIOGRAPHY

References updated: 09 September 2020

Abbreviations: ER, extended release; IR, immediate release; SR, sustained release.

Zimmerman HJ. Drugs used in the treatment of hypercholesterolemia and hyperlipidemia. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 660-2. (Expert review of hepatotoxicity published in 1999; jaundice is reported in 3% of patients on nicotinic acid for a year or more; sustained release forms are more likely to cause injury; niacin may have direct, intrinsic hepatotoxicity).
De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic medications. Lipid lowering agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 519-40. (Review of hepatotoxicity of lipid lowering agents; niacin is available over-the-counter and patients may take it in toxic amounts, >3 g daily of regular and lower amounts of sustained release niacin).
Gurgle HE, Blumenthal DK. Drug therapy for dyslipidemias. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2013, pp. 605-18. (Textbook of pharmacology and therapeutics; niacin inhibits triglyceride synthesis which results in a decrease in hepatic LDL production and release).
Rivin AU. (1959). Jaundice occurring during nicotinic acid therapy for hypercholesterolemia. J Am Med Assoc. (23 year old man with familial hypercholesterolemia developed jaundice and pruritus after 18 months of niacin [3 g/day] therapy [bilirubin 7.4 mg/dL, AST 91 U/L, Alk P 3 times ULN], resolving within 20 days of stopping).
Christensen NA, Achor RW, Berge KG, Mason HL. (1961). Nicotinic acid treatment of hypercholesteremia. Comparison of plain and sustained-action preparations and report of two cases of jaundice. JAMA. (Comparison of regular vs sustained release [SR] niacin found more adverse events and 2 cases of jaundice with SR form; 56 year old man tolerated regular niacin but developed abdominal pain and nausea after 4 days of the same dose of SR niacin [bilirubin 6.4 mg/dL, AST 20 times ULN, Alk P slightly elevated], resolving within 4 weeks of stopping; 51 year old man developed jaundice in first week of SR niacin therapy [bilirubin 3.5 mg/dL, AST 3 times and Alk P 3 times ULN], resolving in 7 weeks).
Pardue WO. (1961). Severe liver dysfunction during nicotinic acid therapy. JAMA. (58 year old man developed edema 6 months after starting niacin [3 g daily] with bilirubin 1.3 mg/dL, AST 43 U/L, Alk P ~twice normal, albumin 2.0 g/dL, resolving in 3 months of stopping niacin).
Parsons WB. (1961). Studies of nicotinic acid use in hypercholesterolemia. Arch Intern Med. (Among 36 patients treated with niacin [3-6 g/day] for more than a year, 8 had increase in BSP retention and 5 had AST elevations which resolved on stopping; 3 case reports with cirrhosis in one and mild jaundice in two, resolving with stopping).
Kohn RM, Montes M. (1969). Hepatic fibrosis following long acting nicotinic acid therapy: a case report. Am J Med Sci. (54 year old man found to have jaundice 4 years after starting niacin for hypercholesterolemia [bilirubin 11.8 mg/dL, ALT 59 U/L and Alk P 3 times ULN], resolving with stopping niacin; autopsy 2 years later showed posthepatitic cirrhosis).
Winter SL, Boyer JL. (1973). Hepatic toxicity from large doses of Vitamin B (nicotinamide). N Engl J Med. (35 year old man developed nausea and vomiting 18 months after starting nicotinamide for schizophrenia [bilirubin 5.6 mg/dL], resolving with stopping and recurring within 10 days of restarting excessively high doses [9 g/day] [bilirubin 4.9, ALT 2640 U/L]).
Sugerman AA, Clark CG. (1974). Jaundice following the administration of niacin. JAMA. (69 year old man developed confusion and jaundice 18 months after starting niacin [750 mg/day] [bilirubin 8.3 rising to 19.6 mg/dL, AST 55 U/L, Alk P 205 U/L], worsening for 2 weeks and then resolving slowly over 6 months).
Einstein N, Baker A, Galper J, Wolfe H. (1975). Jaundice due to nicotinic acid therapy. Am J Dig Dis. (23 year old woman developed jaundice 2.5 years after starting niacin [3 g/day] [bilirubin 30.4 mg/dL, ALT 136 U/L, Alk P 3 times ULN], resolving within 1 month of stopping).
Patterson DJ, Dew EW, Gyorkey F, Graham DY. (1983). Niacin hepatitis. South Med J. (41 year old man developed recurrent jaundice on high doses of niacin [bilirubin 7.2 mg/dL, ALT 3300 U/L, Alk P 542 UL, prothrombin time 28.5 sec], resolving within 2 months of stopping: Case 1).
Knopp RH, Ginsberg J, Albers JJ, Hoff C, Ogilvie JT, Warnick GR, Burrows E, Retzlaff B, Poole M. (1985). Contrasting effects of unmodified and time-release forms of niacin on lipoproteins in hyperlipidemic subjects: clues to mechanism of action of niacin. Metabolism. (Comparison of safety and efficacy of regular vs slow release [SR] niacin in 68 patients; flushing was less with SR form, but other side effects including AST and Alk P elevations were more common).
Canner PL, Berge KG, Wenger NK, Stamler J, Friedman L, Prineas RJ, Friedewald W. (1986). Fifteen year mortality on coronary drug project patients: long-term benefit with niacin. J Am Coll Cardiol. (Controlled trial of niacin vs placebo in 8341 men with coronary artery disease showed evidence of benefit in survival during long term follow up).
Clementz GL, Holmes AW. (1987). Nicotinic acid-induced fulminant hepatic failure. J Clin Gastroenterol. (46 year old man developed nausea 1 month after starting niacin [3 g/day] [bilirubin 1.1 mg/dL, ALT 413 U/L], resolving with stopping, but recurrence with jaundice 10 weeks after restarting niacin [bilirubin 6.6 mg/dL, ALT 6220 U/L, Alk P 239 U/L, protime 90 sec], progressing over 3 days to stage 3 coma, but then rapid improvement, and all tests were normal 4 months later).
Ferenchick G, Rovner D. (1989). Hepatitis and hematemesis complicating nicotinic acid use. Am J Med Sci. (20 year old man developed nausea and vomiting 7 days after starting high doses of niacin [6 g daily] [bilirubin 2.4 mg/dL, ALT 42→733 U/L, and protime of 17.6 sec], with rapid recovery on stopping).
Mullin GE, Greenson JK, Mitchell MC. (1989). Fulminant hepatic failure after ingestion of sustained release nicotinic acid. Ann Intern Med. (44 year old man developed nausea, abdominal pain and fever 3 days after switching from regular niacin [6 g/day] to the same dose in a sustained release form [bilirubin 9.8 mg/dL, ALT 5186 U/L, Alk P 372 U/L, protime 64 sec], developing coma and undergoing liver transplant with uneventful recovery).
Henkin Y, Johnson KC, Segrest JP. (1990). Rechallenge with crystalline niacin after drug-induced hepatitis from sustained-release niacin. JAMA. (Two men and one woman, ages 52 to 62 years, developed acute liver injury [bilirubin 0.8, 7.1 and 0.5 mg/dL, ALT 700, 870 and 55 U/L, Alk P 56, 2325 and 85 U/L] after 1-24 weeks of sustained release niacin, all three of whom then tolerated same dose [2-4 g/day] of regular, crystalline niacin for prolonged period).
Hodis HN. (1990). Acute hepatic failure associated with the use of low-dose sustained release niacin. JAMA. (32 year old man developed nausea 2 months after starting SR niacin [500 mg daily] [bilirubin 11.9 mg/dL, ALT >9000 U/L, LDH 12,700 U/L and Alk P 209 U/L, prothrombin index <5%], progressing to hepatic coma, but full spontaneous recovery and normal liver tests 8 weeks later).
Henkin Y, Oberman A. (1991). Hurst Dc, Segrest JP. Niacin revisited: clinical observations on an important but underutilized drug. Am J Med. (Retrospective analysis of 82 patients treated with niacin for dyslipidemia from 1987-90; none of 65 on regular niacin but 8 of 15 on sustained release niacin [4 different brands] developed liver injury, even in low doses; all but one with hepatocellular pattern of enzymes [ALT 810-970 U/L, Alk P 56-2325 U/L], one jaundiced, all recovered).
Etchason JA, Miller TD, Squires RW, Allison TG, Gau GT, Martilla JK, Kottke BA. (1991). Niacin-induced hepatitis: a potential side effect with low-dose time-release niacin. Mayo Clin Proc. (Description of 5 cases of liver injury during sustained release [SR] niacin therapy [1.5 to 3 g/day] arising a few days to months after switching to SR or raising dose, all symptomatic but none jaundiced, all resolved promptly with stopping).
Schwab RA, Bachhuber BH. (1991). Delirium and lactic acidosis caused by ethanol and niacin coingestion. Am J Emerg Med. (44 year old man with “toxic delirium” attributed to alcohol and niacin [3 g/day] [bilirubin 0.8 mg/dL, ALT 230 U/L, Alk P 96 U/L, lactic acid 9.5 mmol/L], with resolution of delirium despite continuing niacin and resolution of ALT elevations on decreasing niacin dose).
Fischer DJ, Knight LL, Vestal RE. (1991). Fulminant hepatic failure following low-dose sustained release niacin therapy in hospital. West J Med. (56 year old man developed jaundice 6 days after hospitalization for bronchitis and administration of SR niacin [2 g/day] [bilirubin 6.0 mg/dL, ALT 834 U/L, Alk P 270 U/L], progressing to hepatic failure and death 4 days later).
Rader JI, Calvert RJ, Hathcock JN. (1992). Hepatic toxicity of unmodified and time-release preparations of niacin. Am J Med. (Review from FDA of literature on hepatotoxicity from unmodified [mostly taking >3 g/day] and sustained release [SR] form of niacin [0.5-3 g/day]; in 10 cases, liver disease developed shortly after switching to SR form).
Dalton TA, Berry RS. (1992). Hepatotoxicity associated with sustained-release niacin. Am J Med. (67 year old woman developed fatigue followed by agitation and stupor, starting 2 days after switching from regular to SR niacin [bilirubin 0.5 mg/dL, ALT 105 U/L, Alk P 446 U/L, protime 15.8 sec], resolving within 1 month of stopping).
Dearing BD, Lavie CJ, Lohmann TP, Genton E. (1992). Niacin-induced clotting factor synthesis deficiency with coagulopathy. Arch Intern Med. (3 men, ages 44 to 57 years, on SR niacin for 1-3 months, developed coagulopathy with minimal liver test abnormalities [bilirubin 0.7-1.0 mg/dL, ALT 56-86 U/L, protime 17.2-19.9], with low triglyceride levels and recovery within 1-2 weeks upon stopping and recurrence on restarting SR niacin [1 patient], but not regular niacin [1 patient]).
Lawrence SP. (1993). Transient focal hepatic defects related to sustained-release niacin. J Clin Gastroenterol. (37 year old woman developed fatigue and nausea 1 month after reaching SR niacin dose of 4 g/day [ALT 58 U/L, Alk P 503 U/L, bilirubin 0.8 mg/dL], but niacin continued and 3 months later CT showed 2 hypo-dense central defects in liver [interpreted as focal fat]; both enzyme elevations and imaging abnormality resolving with stopping niacin).
Jacobson TA, Amorosa LF. (1994). Combination therapy with fluvastatin and niacin in hypercholesterolemia: a preliminary report on safety. Am J Cardiol. (Controlled trial of fluvastatin vs placebo followed by addition of niacin [up to 3 g/day] in 74 patients; ALT elevations occurred in 5.3% on fluvastatin and niacin compared to 6.5% of niacin alone; no case of clinically apparent liver injury and no elevation >3 times ULN).
McKenney JM, Proctor JD, Harris S, Chinchili VM. (1994). A comparison of the efficacy and toxic effects of sustained- vs immediate-release niacin in hypercholesterolemic patients. JAMA. (Controlled trial of immediate- [IR] vs sustained release [SR] niacin for 6 weeks in 46 patients with hypercholesterolemia; SR form was less likely to cause flushing, but ALT elevations >3 times ULN occurred in 12 of 23 patients on 2-3 g/day of SR [5 symptomatic], but none of 23 on IR niacin).
Coppola A, Brady PG, Nord HJ. (1994). Niacin-induced hepatotoxicity: Unusual presentations. South Med J. (Four cases of symptomatic hepatotoxicity during therapy with SR niacin for 3 or more months, with bilirubin 0.6-1.7 mg/dL, ALT 34-144 U/L, and Alk P 70 to 136 U/L, two had focal fat on CT scan, all resolved within 1-2 months).
Patel SD, Taylor HC. (1994). Intrahepatic cholestasis during nicotinic acid therapy. Cleve Clin J Med. (61 year old man developed jaundice a year after starting regular niacin [3 g/day] [bilirubin 8.4 mg/dL, Alk P 1260, ALT 360 U/L], resolving within 6 weeks of stopping).
Schwenk TL, Fisher M. (1994). Hepatitis caused by low-dose sustained-release niacin. J Am Board Fam Pract. (36 year old man developed severe fatigue 2 years after starting niacin and 2 months after switching to an SR form [500 mg/day] [bilirubin not given, ALT 556 U/L, Alk P 156 U/L], resolving within 5 weeks of stopping SR niacin).
Reimund E, Ramos A. (1994). Niacin-induced hepatitis and thrombocytopenia after 10 years of niacin use. J Clin Gastroenterol. (32 year old man developed fatigue after taking niacin [3 g/day] for 3 years [bilirubin 1.2 mg/dL, ALT 139 U/L, Alk P 208 U/L], values returning to almost normal within 3 weeks of stopping).
Brown WV. (1995). Niacin for lipid disorders: Indications, effectiveness, and safety. Postgrad Med. (Review of efficacy and safety of niacin therapy of dyslipidemia; doses of niacin above 3 g per day and use of SR formulations are associated with higher rates of hepatotoxicity).
Capuzzi DM, Guyton JR, Morgan JM, Goldberg AC, Kreisberg RA, Brusco OA, Brody J. (1998). Efficacy and safety of an extended-release niacin (Niaspan): a long-term study. Am J Cardiol. (Open label study of ER niacin [1-3 g/day] in 517 patients for up to two years; flushing episodes in 75%, ALT elevations >twice ULN occurred in <1%, and none had levels >3 times ULN).
Tatò F, Vega GL, Grundy SM. (1998). Effects of crystalline nicotinic acid-induced hepatic dysfunction on serum low-density lipoprotein cholesterol and lecithin cholesteryl acyl transferase. Am J Cardiol. (Three men, ages 46-66 years, developed mild nonspecific symptoms and hepatic dysfunction after 4 months of taking regular niacin with decrease in serum proteins, rise in prothrombin time and marked decline in cholesterol and triglycerides, but minimal increase in routine liver tests [bilirubin 0.6-1.2 mg/dL, ALT 16-73 U/L, Alk P 75-225 U/L], resolving within 4 weeks of stopping).
Rourk RM, Rehman NU. (1998). Niacin. Help for your cholesterol--harm for your liver. N C Med J. (46 year old woman developed fatigue and jaundice a few weeks after reaching a dose of 10 g/day of SR niacin [bilirubin 6.2 mg/dL, ALT 2081 U/L, Alk P 295 U/], resolving within 3 weeks of stopping).
Morgan JM, Capuzzi DM, Guyton JR. (1998). A new extended-release niacin (Niaspan): efficacy, tolerability, and safety in hypercholesterolemic patients. Am J Cardiol. (Controlled trial of two doses of extended release niacin [ER: Niaspan] vs placebo in 96 patients; 83-88% had flushing episodes and 1 had ALT elevations >3 times ULN, but it resolved despite remaining on niacin).
Kristensen T, Olcott EW. (1999). Effects of niacin therapy that simulate neoplasia: hepatic steatosis with concurrent hepatic dysfunction. J Comput Assist Tomogr. (52 year old man developed nausea 5 months after starting niacin [2 g/day] [bilirubin 1.6 mg/dL, ALT 110 U/L, Alk P 304 U/L] and hyperechoic lesions in liver by CT [interpreted as focal fat], resolving with stopping niacin).
Scheer MS, Perlmutter S, Ross W, Katz DS. (1999). Ultrasonographic findings in niacin-induced hepatitis. J Ultrasound Med. (50 year old man developed abdominal pain 8 weeks after starting SR niacin [total daily dose 2 g/day] [bilirubin 0.9 mg/dL, AST 168 U/L, Alk P 97 U/L] and ultrasound showing hypoechoic lesions and “starry sky liver”).
Kashyap ML, McGovern ME, Berra K, Guyton JR, Kwiterovich PO, Harper WL, Toth PD, et al. (2002). Long-term safety and efficacy of a once-daily niacin/lovastatin formulation for patients with dyslipidemia. Am J Cardiol. (Open label trial of the fixed combination of lovastatin [10 mg] and extended release [ER] niacin [500 mg] [Advicor] escalating to 4 daily in 814 patients; 4 [0.5%] had ALT elevations >3 times ULN and 3 were withdrawn for abnormal liver tests, but none were clinically apparent).
Gavilán JC, Bermúdez FJ, Belmonte A, González-Santos P. (2002). Med Clin (Barc). (50 year old man developed jaundice, pruritus and fatigue during the 6th year of taking niacin in doses of 2.5-3.5 g/day [bilirubin 5.3 mg/dL, ALT 119 U/L, Alk P 781 U/L, prothrombin index 36%], resolving within 8 weeks of stopping).
Bays HE, Dujovne CA, McGovern ME, White TE, Kashyap ML, Hutcheson AG, Crouse JR, Advicor Versus Other Cholesterol-Modulating Agents Trial Evaluation. (2003). Comparison of once-daily, niacin extended-release/lovastatin with standard doses of atorvastatin and simvastatin (the Advicor Versus Other Cholesterol-Modulating Agents Trial Evaluation [ADVOCATE]). Am J Cardiol. (Controlled trial comparing lovastatin combined with niacin to atorvastatin or simvastatin alone in 315 patients for 16 weeks; no patient had confirmed ALT elevation >3 times ULN).
Pieper JA. (2003). Overview of niacin formulations: differences in pharmacokinetics, efficacy, and safety. Am J Health Syst Pharm. (Review of pharmacology, efficacy and safety of niacin as a lipid lowering agent; the extended release [ER] form has intermediate rates of dissolution and absorption between regular and sustained release [SR] niacin and appears to have lower rates of flushing compared to regular and less hepatotoxicity compared to SR forms).
Zhao XQ, Morse JS, Dowdy AA, Heise N, DeAngelis D, Frohlich J, Chait A, et al. (2004). Safety and tolerability of simvastatin plus niacin in patients with coronary artery disease and low high-density lipoprotein cholesterol (The HDL Atherosclerosis Treatment Study). Am J Cardiol. (Controlled trial of simvastatin and niacin vs placebo in 160 patients for up to 3 years; side effects were similar in the two groups with AST elevations >3 times ULN in 2 patients on simvastatin/niacin and one on placebo).
Alsheikh-Ali AA, Karas RH. (2007). Safety of lovastatin/extended release niacin compared with lovastatin alone, atorvastatin alone, pravastatin alone, and simvastatin alone(from the United States Food and Drug Administration adverse event reporting system). Am J Cardiol. (Analysis of MedWatch reports of adverse events found no excess in liver related adverse event reports per million prescriptions of lovastatin alone [2.3] vs niacin alone [2.5] vs the combination [3.2], but slightly higher rates with atorvastatin [4.5], simvastatin [5.7] and pravastatin [4.9], but data are based upon spontaneous reporting).
Bhardwaj SS, Chalasani N. (2007). Lipid-lowering agents that cause drug-induced hepatotoxicity. Clin Liver Dis. (Review of hepatotoxicity of lipid lowering agents; injury from niacin is most common with sustained release forms; onset of injury ranges from 1 week to 2 years after starting drug, usually subsiding rapidly with stopping; acute liver failure occurs, but is rare).
Guyton JR, Bays HE. (2007). Safety considerations with niacin therapy. Am J Cardiol. (Expert review of safety of niacin; in contrast to the over-the-counter sustained release forms, the prescription requiring extended release form of niacin has not been associated with a higher rate of hepatotoxicity).
Birjmohun RS, Kastelein JJ, Poldermans D, Stroes ES, Hostelek U, Assman G. (2007). Safety and tolerability of prolonged-release nicotinic acid in statin-treated patients. Curr Med Res Opin. (Open label study of combination of extended release niacin [Niaspan] added to preexisting statin therapy for 6 months in 1053 patients; flushing in 40%, no significant change in AST or ALT and no clinically apparent hepatotoxicity).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, only one case was attributed to niacin: 53 year old man developed nausea and fatigue 2 months after starting SR niacin [bilirubin 2.3 mg/dL, ALT 595 U/L, Alk P 132 U/L], resolving within 2 weeks of stopping).
Bays H. (2008). Safety of niacin and simvastatin combination therapy. Am J Cardiol. (Review of safety of the combination of niacin and simvastatin; ALT elevations associated mostly with slow release [SR] rather than the extended [ER] or intermediate [IR] release formulations of niacin).
Guyton JR, Brown BG, Fazio S, Polis A, Tomassini JE, Tershakovec AM. (2008). Lipid-altering efficacy and safety of ezetimibe/simvastatin coadministered with extended-release niacin in patients with type IIa or type IIb hyperlipidemia. J Am Coll Cardiol. (Controlled trial comparing niacin alone vs simvastatin/ezetimibe vs the triple combination for 24 weeks in 1220 patients with hypercholesterolemia; confirmed ALT elevations >3 times ULN occurred in 0.4% on niacin, 0.4% on simvastatin/ezetimibe and 0.5% on all three).
Kamanna VS, Kashyap ML. (2008). Mechanism of action of niacin. Am J Cardiol. (Niacin inhibits hepatocyte diacylglycerol acyltransferase-2, an important enzyme in triglyceride synthesis, making triglycerides less available for uptake into lipoprotein particles and resulting in accelerated degradation of apo B and decreased secretion of VLDL and LDL particles by the liver).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to niacin or nicotinamide).
McKenney J, Bays H, Koren M, Ballantyne CM, Paolini JF, Mitchel Y, Betteridge A, et al. (2010). Safety of extended-release niacin/laropiprant in patients with dyslipidemia. J Clin Lipidol. (Analysis of results from 4747 patients enrolled in 6 large studies of ER niacin with or without laropiprant [which decreases niacin related flushing] compared to simvastatin or placebo; ALT or AST elevations >3 times ULN occurred in 0.5%-1% of niacin recipients compared to 0.9% on simvastatin, and no patient developed "treatment related hepatitis").
Byrd C, Mowrey KA. (2010). Lipid and transaminase concentrations after formulary conversion of Niaspan to Slo-Niacin. Am J Health Syst Pharm. (Retrospective analysis of effects of converting 142 patients from a prescription ER niacin [Niaspan] to an over-the-counter SR niacin [Slo-Niacin]; ALT levels increased in 31% of patients, but none rose to above 3 times ULN).
Lavie CJ, Milani RV. (2011). Efficacy and safety of sustained-release niacins. Am J Health Syst Pharm. (Editorial regarding Byrd [2010] stressing the lack of safety of some formulations of SR-niacin).
AIM-HIGH Investigators, Boden WE, et al. (2011). Niacin in patients with low HDL cholesterol levels receiving intensive statin therapy. N Engl J Med. (3414 patients with cardiovascular disease were treated with statins and ezetimibe and either ER niacin or placebo and followed for cardiovascular outcomes; niacin use was associated with a rise in HDL cholesterol and fall in triglycerides levels, but clinical outcomes were not affected; adverse events were rare with liver test abnormalities arose in 0.5% of placebo and 0.8% of niacin recipients).
Aramwit P, Srisawadwong R, Supasyndh O. (2012). Effectiveness and safety of extended-release nicotinic acid for reducing serum phosphorus in hemodialysis patients. J Nephrol. (Among 28 hemodialysis patients with hyperphosphatemia randomized to receive ER niacin [0.5-1 g/day] or placebo for 12 weeks, no patient developed significant serum enzyme elevations).
Dunatchik AP, Ito MK, Dujovne CA. (2012). A systematic review on evidence of the effectiveness and safety of a wax-matrix niacin formulation. J Clin Lipidol. (Analysis of 4 published studies of SR niacin [Endur-acin] in 635 hyperlipidemic patients treated for 8-38 weeks, showed mild, overall changes in Alk P and AST levels, but none rose above 1.6 times baseline values; one patient developed anicteric but symptomatic hepatitis that resolved upon stopping niacin).
Ali EH, McJunkin B, Jubelirer S, Hood W. (2013). Niacin induced coagulopathy as a manifestation of occult liver injury. W V Med J. (61 year old man was found to have abnormal coagulation studies with minimal ALT elevations, having been on ER niacin for 4 years [INR 1.5, platelets 117,000/μL, bilirubin 1.4 mg/dL, ALT 44 U/L], resolving within 4 weeks of stopping).
HPS2-THRIVE Collaborative Group. (2013). HPS2-THRIVE randomized placebo-controlled trial in 25 673 high-risk patients of ER niacin/laropiprant: trial design, pre-specified muscle and liver outcomes, and reasons for stopping study treatment. Eur Heart J. (Among 25,673 subjects stabilized on statin therapy and then randomized to receive niacin with laropiprant versus placebo, serum ALT elevations above 3 times ULN occurred in 0.30% of patients on niacin vs 0.14% on placebo per year and occurrence of ALT elevations with jaundice was rare [<0.01%]).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to niacin).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attribute to niacin).
HPS2-THRIVE Collaborative Group, Landray MJ, Haynes R, Hopewell JC, Parish S, Aung T, Tomson J, Wallendszus K, et al. (2014). Effects of extended-release niacin with laropiprant in high-risk patients. N Engl J Med. (Among 25,673 adults with vascular disease treated with statins with or without niacin combined with laropiprant [to decrease flushing reactions] for a median of 3.9 years, LDL cholesterol levels were lower with niacin [by 10 mg/dL] and HDL levels were higher [by 6 mg/dL] but rates of vascular events were similar [13.2% vs 13.7%], while side effects were more common particularly diabetes and myalgias [but not hepatic events]).
Anderson TJ, Boden WE, Desvigne-Nickens P, Fleg JL, Kashyap ML, McBride R, Probstfield JL. (2014). AIM-HIGH Investigators. Safety profile of extended-release niacin in the AIM-HIGH trial. N Engl J Med. (Editorial in response to HPS2-THRIVE study [2014] mentions that side effects of niacin including myopathy, bleeding and glucose elevations were also seen in the AIM-HIGH trial [2011]).
Lloyd-Jones DM. (2014). Niacin and HDL cholesterol--time to face facts. N Engl J Med. (Editorial in response to HPS2-THRIVE study [2014] concludes that niacin has “an unacceptable toxicity profile for the majority of patients, and it should not be used routinely”).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, United States Drug Induced Liver Injury Network, et al. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 363 [36%] were attributed to antibiotics, 5 [0.6%] of which were attributed to niacin).
McKenney J, Bays H, Gleim G, Mitchel Y, Kuznetsova O, Sapre A, Sirah W, et al. (2015). Safety and tolerability of extended-release niacin-laropiprant: pooled analyses for 11,310 patients in 12 controlled clinical trials. J Clin Lipidol. (Analysis of 12 clinical studies with 12,310 patients treated for 12-52 weeks with niacin/laropiprant or niacin alone or a statin for rates of adverse events indicated that episodes of bleeding and myopathy were no more frequent with niacin/laropiprant than niacin alone and ALT elevations occurred at similar rates in all 3 groups: 1.4% vs 1.0% vs 1.5%).
Schaffellner S, Stadlbauer V, Sereinigg M, Mìller H, Högenauer C, Fickert P, Krumnikl J, et al. (2017). Niacin-associated acute hepatotoxicity leading to emergency liver transplantation. Am J Gastroenterol. (22 year old female athlete took a single dose of 20 gm of native niacin and developed acute liver failure within 3 days [bilirubin 3.6 mg/dL, ALT 12,594 U/L, Alk P 165 U/L, INR above 8.9], undergoing successful liver transplantation within 12 hours).
Durham SH, Covington EW, Clemmons KJ. (2018). Hepatotoxicity upon using niacin to pass a drug test: A case report. Journal of the American Pharmacists Association. (25 year old man with HIV infection on long term antiretroviral therapy was found to have elevated serum aminotransferase levels without jaundice on a routine clinic visit [ALT 158 U/L, AST 982 U/L], which rapidly resolved at which point he admitted to taking large doses of niacin to mask a positive urine test for marijuana use done for a job interview).
(2019). Lipid-lowering drugs. Med Lett Drugs Ther. (Concise summary of drugs for treating hypercholesterolemia states that there is no evidence that niacin improves cardiovascular outcomes and it has troublesome adverse events including hepatotoxicity).
Haynes R, Valdes-Marquez E, Hopewell JC, Chen F, Li J, Parish S, Landray MJ, HPS2-THRIVE Collaborative Group, HPS2-THRIVE Writing Committee members, HPS2-THRIVE Steering Committee members, et al. (2019). Serious adverse effects of extended-release niacin/Laropiprant: results from the Heart Protection Study 2-Treatment of HDL to Reduce the Incidence of Vascular Events (HPS2-THRIVE) Trial. Clin Ther. (Reanalysis of the adverse events that arose in the HPS2-THRIVE study [2014] for risk factors for the excess in bleeding episodes, infection and diabetes found no specific risk factors; no analysis of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Niacin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=niacin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Niacin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=niacin)